# Dupilumab

## OVERVIEW

### Introduction

Dupilumab is a human monoclonal antibody to the interleukin-4 (IL-4) receptor which leads to a decrease in production inflammatory mediators of allergic symptoms and is used in the therapy of atopic dermatitis. Dupilumab therapy has not been associated with serum enzyme elevations or to instances of clinically apparent drug induced liver injury.

### Background

Dupilumab (doo pil' ue mab) is a recombinant human IgG4 monoclonal antibody to the IL-4 receptor subunit alpha which blocks the activation of the IL-4 signaling pathway. IL-4 plays a critical role in Th-2 inflammatory reactions, important in mediation of allergic and atopic conditions. Therapy with dupilumab has been shown to alleviate signs and symptoms of atopic dermatitis and asthma. Dupilumab was approved for use in the United States in 2017 for therapy of moderate-to-severe atopic dermatitis that does not respond adequately to topical treatments. It is under investigation as therapy of other allergic conditions including asthma. Dupilumab is available in solution in single dose prefilled syringes of 300 mg in 2 mL under the brand name Dupixent. The recommended dose is an initial subcutaneous injection of 600 mg followed by 300 mg every other week. Side effects are not common and generally mild, but can include injection site reactions, conjunctivitis, keratitis and dry eyes. Rare but potentially severe adverse events include hypersensitivity reactions and herpes simplex infections.

### Hepatotoxicity

In several large randomized, placebo controlled trials, serum enzyme and bilirubin levels did not change during dupilumab therapy and there were no reported liver related serious adverse events or causes for early discontinuation. There have been no published reports of clinically apparent acute liver injury attributed to dupilumab therapy, but it has had limited general clinical use. Thus, liver injury from dupilumab must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Liver Injury

Dupilumab is a human monoclonal antibody and is unlikely to be inherently hepatotoxic. Recombinant proteins are often metabolized in the cells on which they act but are also metabolized in the liver, largely to small peptides and amino acids which may be reused to synthesize proteins and are unlikely to be toxic or immunogenic. Inhibition of IL-4 signaling does not appear to have serious infectious consequences, although reactivation of herpes simplex infections may be an effect of the agent and its effects (or lack of effects) on hepatitis B virus or tuberculosis infections have not been clearly defined.

Drug Class: Dermatologic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dupilumab – Dupixent®

DRUG CLASS

Dermatologic Agents, Atopic Dermatitis

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dupilumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Dupilumab | 1190264-60-8 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 01 August 2018

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; "the biological immuno-suppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; dupilumab is not specifically mentioned).
Barnes PJ. Pulmonary pharmacology. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1031-65. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Drugs for asthma and COPD. Treat Guidel Med Lett 2013; 11 (132): 75-86. (Concise summary of guidelines for therapy of asthma, discusses omalizumab [monoclonal anti-IgE] but not dupilumab). 23896773
Wenzel S, Ford L, Pearlman D, Spector S, Sher L, Skobieranda F, Wang L, et al. Dupilumab in persistent asthma with elevated eosinophil levels. N Engl J Med 2013; 368: 2455-66. (Among 104 adults with moderate-to-severe asthma and eosinophilia who were treated with dupilumab or placebo weekly for 12 weeks, clinical exacerbations occurred in only 6% of dupilumab- vs 44% of placebo treated subjects while adverse event rates were similar, and “no clinically significant changes in… clinical laboratory testing…were reported in either group”). 23688323
Ortega HG, Liu MC, Pavord ID, Brusselle GG, FitzGerald JM, Chetta A, Humbert M, et al.; MENSA Investigators. Mepolizumab treatment in patients with severe eosinophilic asthma. N Engl J Med 2014; 371: 1198-207. (Among 576 patients with severe eosinophilic asthma treated with mepolizumab [75 mg iv or 100 mg sc] or placebo every 4 weeks for 32 weeks, rates of exacerbation were less with mepolizumab [0.9 to 0.9 yearly] vs placebo [1.7 yearly] and side effects were similar; no mention of ALT elevations or hepatotoxicity). 25199059
Beck LA, Thaçi D, Hamilton JD, Graham NM, Bieber T, Rocklin R, Ming JE, et al. Dupilumab treatment in adults with moderate-to-severe atopic dermatitis. N Engl J Med 2014; 371: 130-9. (Among 206 patients with moderate-to-severe atopic dermatitis treated in 3 controlled trials of 4 and 12 weeks of therapy, “clinically significant values for clinical laboratory tests…assessments were balanced between treatment groups;” no mention of ALT elevations or hepatotoxicity). 25006719
Simpson EL, Bieber T, Guttman-Yassky E, Beck LA, Blauvelt A, Cork MJ, et al. SOLO 1 and SOLO 2 Investigators. Two phase 3 trials of dupilumab versus placebo in atopic dermatitis. N Engl J Med 2016; 375: 2335-48. (Among 1379 patients with refractory atopic dermatitis treated in 2 controlled trials, response rates were greater with dupilumab [36% to 38%] than placebo [8% to 10%], while adverse event rates were similar except for injection site reactions [8% to 19% vs 6%] and conjunctivitis [3% to 5% vs 1%], and there were no liver related serious adverse events or causes of early discontinuation). 27690741
Wenzel S, Castro M, Corren J, Maspero J, Wang L, Zhang B, Pirozzi G, et al. Dupilumab efficacy and safety in adults with uncontrolled persistent asthma despite use of medium-to-high-dose inhaled corticosteroids plus a long-acting β2 agonist: a randomised double-blind placebo-controlled pivotal phase 2b dose-ranging trial. Lancet 2016; 388: 31-44. (Among 769 adults with asthma refractory to standard therapies treated with dupilumab [200 or 300 mg every 2 or 4 weeks] or placebo for 24 weeks, lung function improved and exacerbations were reduced with dupilumab and adverse events were similar in all groups; no mention of ALT elevations or liver related severe adverse events). 27130691
Chung KF. Dupilumab: a potential new treatment for severe asthma. Lancet 2016; 388: 3-4. (Editorial in response to Wenzel [2016] on the potential role of dupilumab in management of severe asthma). 27130690
Bachert C, Mannent L, Naclerio RM, Mullol J, Ferguson BJ, Gevaert P, Hellings P, et al. Effect of Subcutaneous dupilumab on nasal polyp burden in patients with chronic sinusitis and nasal polyposis: a randomized clinical trial. JAMA 2016; 315: 469-79. (Among 60 patients with chronic sinusitis and nasal polyps treated with dupilumab or placebo for 16 weeks, adverse event rates were similar in the two groups; no mention of ALT elevations or hepatotoxicity). 26836729
Thaçi D, Simpson EL, Beck LA, Bieber T, Blauvelt A, Papp K, Soong W, et al. Efficacy and safety of dupilumab in adults with moderate-to-severe atopic dermatitis inadequately controlled by topical treatments: a randomised, placebo-controlled, dose-ranging phase 2b trial. Lancet 2016; 387: 40-52. (Among 380 adults with moderate-to-severe atopic dermatitis treated with different regimens of dupilumab or placebo for 16 weeks, clinical responses were more frequent with dupilumab as were adverse events including injection site reactions [7% vs 3%], conjunctivitis [7% vs 3%], and herpes infections [8% vs 2%]; no mention of ALT elevations or liver related adverse events). 26454361
Tsianakas A, Ständer S. Dupilumab: a milestone in the treatment of atopic dermatitis. Lancet 2016; 387: 4-5. (Editorial in response to Thaçi [2016]). 26454359
Blauvelt A, de Bruin-Weller M, Gooderham M, Cather JC, Weisman J, Pariser D, Simpson EL, et al. Long-term management of moderate-to-severe atopic dermatitis with dupilumab and concomitant topical corticosteroids (LIBERTY AD CHRONOS): a 1-year, randomised, double-blinded, placebo-controlled, phase 3 trial. Lancet 2017; 389: 2287-303. (Among 740 adults with moderate-to-severe atopic dermatitis treated with topical corticosteroids and either dupilumab or placebo for 1 year, response rates were higher with dupilumab [39% vs 12%] and adverse events were similar in the two groups; there were no liver related serious adverse events and ALT elevations above 3 times ULN occurred in 2% on placebo and 1% on dupilumab). 28478972
Dupilumab (Dupixent) for moderate to severe atopic dermatitis. Med Lett Drugs Ther 2017; 59 (1519): 64-6. (Concise review of the mechanism of action, clinical efficacy, safety and cost of dupilumab shortly after its approval in the US as therapy of severe atopic dermatitis). 28419072
Chang HY, Nadeau KC. IL-4Rα Inhibitor for Atopic Disease. Cell 2017; 170: 222. (Brief review of the role of the IL-4 receptor in mediation of IL-4 effects in activating inflammatory pathways and the history of development of IL-4 receptor inhibitors as therapy of atopic dermatitis). 28708993
Shirley M. Dupilumab: first global approval. Drugs 2017; 77: 1115-21. (Review of the development of dupilumab, its clinical efficacy and safety; does not mention ALT elevations occurring on therapy or instances of hepatotoxicity). 28547386
de Bruin-Weller M, Thaçi D, Smith CH, Reich K, Cork MJ, Radin A, Zhang Q, et al. Dupilumab with concomitant topical corticosteroid treatment in adults with atopic dermatitis with an inadequate response or intolerance to ciclosporin A or when this treatment is medically inadvisable: a placebo-controlled, randomized phase III clinical trial (LIBERTY AD CAFÉ). Br J Dermatol 2018; 178: 1083-101. (Among 325 patients with refractory atopic dermatitis treated with dupilumab [weekly or every other week] or placebo for 16 weeks, rates of clinical improvement were greater with dupilumab while adverse event rates were similar; there were no treatment related serious adverse events and no “clinically meaningful differences in laboratory values”). 29193016
Castro M, Corren J, Pavord ID, Maspero J, Wenzel S, Rabe KF, Busse WW, et al. Dupilumab efficacy and safety in moderate-to-severe uncontrolled asthma. N Engl J Med 2018; 378: 2475-85. (Among 1902 patients with uncontrolled asthma treated with dupilumab or placebo for 52 weeks, exacerbations of asthma were less with dupilumab and adverse event rates were similar; no mention of ALT elevations or serious hepatic adverse events). 29782217

## OTHER REFERENCE LINKS

1. Recent References on Dupilumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(theophylline/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Dupilumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=theophylline)